# Nucleoside Analogues

## OVERVIEW

The nucleoside analogues are an important class of antiviral agents now commonly used in the therapy of human immunodeficiency virus (HIV) infection, hepatitis B virus (HBV), hepatitis C virus (HCV), cytomegalovirus (CMV), herpes simplex virus (HSV) and varicella-zoster (VZV) infection. The nucleoside analogues resemble naturally occurring nucleosides and act by causing termination of the nascent DNA chain. These agents are generally safe and well tolerated as they are used by the viral, but not human polymerases in DNA replication. Actually, nucleoside analogues are a large class of agents that include drugs for cancer (cytarabine, gemcitabine, mercaptopurine, azacytidine, cladribine, decitabine, fluorouracil, floxuridine, fludarabine, nelarabine), and rheumatologic diseases (azathioprine, allopurinol) and even bacterial infections (trimethoprim). This chapter will focus on the antiviral nucleoside and nucleotide analogues.

The nucleoside analogues used to treat HIV infection are often referred to as reverse transcriptase inhibitors (NRTIs). However, they have activity against both DNA dependent and RNA dependent DNA polymerases. They are believed to inhibit viral replication by several mechanisms, either by competitive inhibition of the viral polymerase or by DNA chain termination. Many of the antiviral nucleoside analogues are blocked at the 3’ hydroxyl group of the deoxyribonucleic acid, which results in failure of elongation of the nascent DNA molecule. Other antiviral nucleoside analogues are negative enantiomers (L-forms: lamivudine, emtricitabine, telbivudine) of the natural (D-form) nucleosides and interfere with replication, partially because of steric hindrance when they are taken up by the viral polymerase or added to the DNA molecule. Nucleoside analogues that are phosphorylated at the 5’ site are often referred to as nucleotide analogues, but this distinction is artificial as these agents (tenofovir, adefovir) are also nucleoside analogues. These features of the structure of nucleoside analogues are important because of the danger that they might be used by human polymerases and incorporated into RNA or DNA, which is the basis of the serious toxicities of the nucleoside analogues.

Nucleoside analogues can cause liver injury by several mechanisms. Most characteristic is a mitochondrial type of hepatic injury that is probably caused by the nucleoside analogue becoming incorporated into or blocking mitochondrial DNA synthesis by the mitochondrial gamma polymerase, leading to a depletion of mitochondria or decrease in their function. Mitochondrial injury can affect multiple tissues thereby causing myopathy, neuropathy, pancreatitis, bone marrow suppression and/or hepatic injury. The hepatic injury is characterized by accumulation of lactic acidosis, microvesicular steatosis and hepatic synthetic failure (LASH). Serum aminotransferase levels may be minimally elevated and jaundice arises late. The most dramatic example of hepatic mitochondrial injury occurred with the drug fialuridine (FIAU), a nucleoside analogue that was withdrawn after several fatalities due to hepatic failure, lactic acidosis and pancreatitis arising 2 to 3 months after initiation of therapy during phase 2 trials in humans. A similar, but rare and less dramatic and partially reversible hepatic mitochondrial injury has been linked to use of didanosine (dideoxyinosine: ddI), zalcitabine (dideoxycytine: ddC), stavudine (d4T) and less commonly to zidovudine (AZT).

Nucleoside analogues can also cause hepatic injury by other mechanisms, such as acute hypersensitivity and perhaps production of toxic intermediates (abacavir, allopurinol), but these forms of liver injury are idiosyncratic and uncommon. Finally, many nucleoside analogues have potent activity against HBV and can cause acute exacerbations of hepatitis B, either early during therapy or more commonly when therapy is suddenly terminated and viral levels rebound.

Thus, nucleoside analogues can cause a direct hepatotoxicity (mitochondrial dysfunction due to their interaction with host polymerase activity), idiosyncratic hepatotoxicity (usually hypersensitivity reaction as with abacavir) or indirect hepatotoxicity as with exacerbation of underlying liver disease (reactivation of hepatitis B after withdrawal of therapy).

The following drug records of antiviral nucleoside analogues are discussed individually. The major virus infections for which they are used are given in parentheses:

- Abacavir (HIV)
- Acyclovir (HSV, VZV)
- Adefovir (HBV)
- Cidofovir (CMV)
- Didanosine (HIV)
- Emtricitabine (HIV, HBV)
- Entecavir (HBV)
- Famciclovir (HSV, VZV)
- Ganciclovir/Valganciclovir (CMV)
- Lamivudine (HBV)
- Remdesivir (COVID)
- Sofosbuvir (HCV)
- Stavudine (HIV)
- Telbivudine (HBV)
- Tenofovir (HIV, HBV)
- Valacyclovir (HSV,VZV)
- Zidovudine (HIV)

## ANNOTATED BIBLIOGRAPHY

References updated: 01 May 2020

Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. (1998). Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of antiretroviral nucleoside analogues).
Ogedegbe AE, Thomas DL, Diehl AM. (2003). Hyperlactataemia syndromes associated with HIV therapy. Lancet Infect Dis. (Review of mechanisms of hyperlactatemia with antiretroviral therapy which occurs most commonly with use of the di-deoxynucleoside analogues, stavudine, didanosine and zidovudine, and is attributable to mitochondrial depletion, but other mechanisms may be involved).
Ofotokun I, Pomeroy C. (2003). Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med. (Review of sex differences in adverse events from antiretroviral agents; mentions that there is higher frequency of mitochondrial toxicity and hypersensitivity reactions in women than men).
Ogedegbe AO, Sulkowski MS. (2003). Antiretroviral-associated liver injury. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN are reported in 7% of patients on zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommends monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated).
Te HS. (2004). Cholestasis in HIV-infected patients. Clin Liver Dis. (Review of causes of cholestasis in HIV infected patients including antiretrovirals).
Hofman P, Nelson AM. (2006). The pathology induced by highly active antiretroviral therapy against human immunodeficiency virus: an update. Curr Med Chem. (Review of pathology of adverse effects of antiretroviral agents with examples of mitochondrial liver injury and cholestasis).
Núñez M. (2006). Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. J Hepatol. (Review of hepatotoxicity of antiretrovirals; elevations in ALT or AST above 5 times ULN occur in 2-18% of HIV positive patients starting therapy, more frequently with HCV or HBV coinfection; combination of protease inhibitors with low dose ritonavir does not seem to increase risk; agents with highest risk are nevirapine and the nonnucleoside reverse transcriptase inhibitors).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (In WHO database of fatal adverse drug reactions from 1968-2003, 4690 reports of drug induced liver fatality; stavudine was 4th most commonly implicated agent [~120 cases]).
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. (2007). Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis. (Among 133 patients with HIV-HCV coinfection who were treated with interferon or peginterferon, 33% had a sustained response and subsequent yearly rate of hepatic events was higher among nonresponders [12.9%] than responders [3.1%]; also more common with receipt of di-deoxynucleosides).
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. (2007). Side effects of HIV therapy. J Dtsch Dermatol Ges. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide] and hyperpigmentation [zidovudine, emtricitabine]).
Gil ACM, Lorenzetti R, Mendes GB, Marcillo AM, Toro AADC, da Silva MTN, dos Santos Vilela MM. (2007). Hepatotoxicity in HIV-infected children and adolescents on antiretroviral therapy. Sao Paulo Med J. (Retrospective analysis in 152 children [ages 1 to 18 years] with HIV infection on antiretroviral therapy; only 14 [10%] had ALT elevations and all were less than 5 times ULN and 4 were also on antituberculosis therapy; rarely used nonnucleoside reverse transcriptase inhibitors).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], and cholestatic hepatitis [many agents]).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Recommendations on use of antiviral therapy in adults with HIV infection, including use of recently approved agents raltegravir, maraviroc and etravirine).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents).
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir).
Ortu F, Weimer LE, Floridia M, Manconi PE. (2010). Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res. (The authors describe an HCV-HIV coinfected woman with hepatotoxicity thought due to indinavir, saquinavir, fosamprenavir, and darunavir. An integrase-inhibitor regimen based on raltegravir, tenofovir, and emtricitabine was given without toxic effects).
Jena A, Sachdeva RK, Sharma A, Wanchu A. (2009). Adverse drug reactions to nonnucleoside reverse transcriptase inhibitor-based antiretroviral regimen: a 24-week prospective study. J Int Assoc Physicians AIDS Care (Chic). (Six month prospective observational study of 100 patients treated with nevirapine or efavirenz with lamivudine and zidovudine/stavudine; 2.8% treated with nevirapine developed severe hepatotoxicity).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 2 cases were attributed to nevirapine, 2 to nelfinavir, 2 to lopinavir, and 1 to efavirenz, but many patients had HCV or HBV coinfection or were taking other potentially hepatotoxic agents).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contains 9036 hepatic adverse drug reactions in children, zidovudine accounting for 106 cases [ranking 8th], lamivudine 45 cases [26th], and nevirapine 37 cases [36th]).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 4 of which were linked to antiretrovirals: 3 to stavudine [with didanosine or nelfinavir] and 1 to abacavir).
(2014). A combination of ledipasvir and sofosbuvir (Harvoni) for hepatitis C. Med Lett Drugs Ther. (Concise summary of the pharmacology, clinical efficacy, safety and costs of the fixed combination of ledipasvir and sofosbuvir in chronic hepatitis C, genotype 1; adverse events include headache, fatigue, nausea, diarrhea and insomnia, but there was no comparison to placebo therapy and the relationship of these nonspecific symptoms to the drugs is unclear).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to antiviral agents).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 (1.3%] of which were attributed to antiviral agents, but only 2 were nucleoside analogues [didanosine and zidovudine]).
Feld JJ, Jacobson IM, Hezode C, Asselah T, Ruane PJ, Gruener N, Abergel A, et al. (2015). Sofosbuvir and velpatasvir for HCV genotype 1, 2, 4, 5, and 6 infection. N Engl J Med. (Among 741 patients with chronic hepatitis C, genotype 1, 2, 4, 5, or 6, who were treated with a placebo [n=91] vs a single tablet, fixed combination of sofosbuvir and velpatasvir [n=624] once daily for 12 weeks, sustained virological response rates were 0% vs 99% and serious adverse events occurred in none vs 2% on antiviral therapy, but no patient had a liver related serious adverse event or death).
https://www.aasld.org/sites/default/files/2019-06/HBVGuidance_Terrault_et_al-2018-Hepatology.pdf (Guidelines on the therapy of chronic hepatitis B from the American Association for the Study of Liver Disease).
https://aasldpubs.onlinelibrary.wiley.com/doi/pdf/10.1002/hep.31060# (https://aasldpubs.onlinelibrary.wiley.com/doi/pdf/10.1002/hep.31060) (Guidelines on the therapy of chronic hepatitis C from the American Association for the Study of Liver Disease).
http://aidsinfo.nih.gov/guidelines/ (Regularly updated guidelines for the use of antiretroviral agents in HIV-1 infected adults, adolescents and children from the National Institutes of Health).